# Mavacamten

## OVERVIEW

### Introduction

Mavacamten is a small molecule inhibitor of cardiac myosin that is used to improve symptoms and functional capacity in patients with symptomatic obstructive hypertrophic cardiomyopathy. Mavacamten is associated with a low rate of serum aminotransferase elevations during therapy but has not been implicated in cases of clinically apparent liver injury.

### Background

Mavacamten (ma va cam’ ten) is a small molecule inhibitor of cardiac myosin that is used to reduce symptoms and increase functional capacity in adults with symptomatic obstructive hypertrophic cardiomyopathy. Hypertrophic cardiomyopathy is a rare genetic disease of the heart characterized by excessive myocardial contractility that leads to thickening of the cardiac left ventricular wall, which can cause obstruction of blood outflow and progressive heart failure. Mavacamten is a small molecule inhibitor of myosin that reduces cardiac muscle contractility and, in animal models of hypertrophic cardiomyopathy, led to a decrease in ventricular wall thickness. In clinical trials in adult patients with symptomatic obstructive hypertrophic cardiomyopathy, mavacamten therapy led to a decrease in ventricular outflow tract obstruction, increase in peak oxygen consumption, and improvement in symptoms in comparison to therapy with placebo. In 2022, mavacamten was given approval in the United States for use in adults with symptomatic obstructive hypertrophic cardiomyopathy. Mavacamten is available in capsules of 2.5, 5, 10, and 15 mg under the brand name Camzyos. The recommended starting dose is 5 mg once daily with subsequent increases or decreases at 4 to 8 week intervals based upon effectiveness and tolerance. Use of the drug requires careful dose titration and echocardiographic monitoring. Common side effects include dizziness, syncope, and dyspnea, and less commonly headache, back pain, arthralgias, fever and cough. Rare but potentially serious adverse events include heart failure, worsening of left ventricular ejection fraction, and atrial fibrillation. For these reasons, mavacamten is available only as a part of a Risk Evaluation and Mitigation Strategy (REMS) that requires training, patient warning, and regular monitoring for echocardiographic changes and symptoms. Based upon animal studies, mavacamten has the potential of embryo-fetal toxicity, and the product label recommends that women of child-bearing potential practice an effective means of birth control.

### Hepatotoxicity

Liver test abnormalities are infrequent in patients treated with myosin inhibitors. In publications of placebo-controlled trials of mavacamten, results of serum aminotransferase, alkaline phosphatase, and bilirubin levels were usually not mentioned. The FDA review of the single large randomized controlled trial of mavacamten mentions that ALT elevations above 3 times the upper limit of normal (ULN) occurred in 2.4% of patients receiving mavacamten vs 3.9% receiving placebo. Moreover, in that study and other open label trials of mavacamten, there were no instances of serum aminotransferase elevations with jaundice. Since its approval and more wide scale use, there have been no reports of clinically apparent liver injury attributed to mavacamten. Clinical experience with mavacamten therapy has been limited, but ongoing trials, observational studies, and adverse event registries have supported its hepatic safety.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which mavacamten might cause serum aminotransferase elevations is not known. Mavacamten suppresses cardiac contractility and in high doses can cause prominent cardiac symptoms which are the dose-limiting adverse events. Mavacamten is metabolized in the liver, largely by CYP 2C19 and to a lesser degree by CYP 3A4, and it is susceptible to drug-drug interactions - moderate to strong inhibitors of the CYPs (which raise drug levels) can increase adverse side effects, whereas moderate to strong inducers of these enzymes (which lower drug levels) may lessen efficacy.

### Outcome and Management

Mavacamten therapy has not been implicated in causing severe liver test abnormalities or clinically apparent liver injury. However, the de novo appearance and persistence of ALT or AST elevations above 3 times the upper limit of the normal range (ULN) should lead to dose adjustment or discontinuation until the cause of the abnormalities has been identified. Any ALT elevation above 10 times the ULN or ALT elevations with symptoms or jaundice should lead to immediate discontinuation. There is no information on possible cross-sensitivity to liver damage with other cardiac myosin inhibitors, such as aficamten.

Drug Class: Cardiovascular Agents, Drugs for hypertrophic cardiomyopathy

Other Drugs in the Subclass: Cardiac myosin inhibitors: Aficamten

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Mavacamten – Camzyos®

DRUG CLASS

Cardiovascular Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Mavacamten)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Mavacamten | 1642288-47-8 | C15H19N3O2 | CID: 117761397

## ANNOTATED BIBLIOGRAPHY

References updated: January 10, 2026

Abbreviations: ULN, upper limit of the normal range.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Expert review of hepatotoxicity of published in 1999; before the availability of cardiac myosin inhibitors such as mavacamten).
Eschenhagen T. Therapy of heart failure. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 527-546. (Textbook of pharmacology and therapeutics, no mention of cardiac myosin inhibitors).
FDA: 2025. Integrated review. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2022/214998Orig1s000TOC.cfm (FDA website with product labels and integrated review of the safety and efficacy of mavacamten provided by the drug sponsor in support of its approval for therapy of symptomatic obstructive hypertrophic cardiomyopathy in the United States, mentions that in a randomized controlled trial in 251 patients, ALT elevations above 3 times ULN occurred in 2.4% of mavacamten vs 3.9% of placebo recipients and there were no liver related serious adverse events).
Davis BJ, Volk H, Nguyen O, Kamna D, Chen H, Barriales-Villa R, Garcia-Pavia P, et al. Safety and efficacy of mavacamten and aficamten in patients with hypertrophic cardiomyopathy. J Am Heart Assoc. 2025;14:e038758.. (Analysis of 10 clinical trials of mavacamten and aficamten in adults with hypertrophic cardiomyopathy, both showed benefit in reducing left ventricular outflow tract obstruction, symptom burden, and exercise parameters and both were “generally well tolerated” with major severe adverse events being heart failure, worsening of left ventricular ejection fraction, and atrial fibrillation; no mention of ALT elevations or hepatotoxicity). 40055855
Olivotto I, Oreziak A, Barriales-Villa R, Abraham TP, Masri A, Garcia-Pavia P, Saberi S, et al.; EXPLORER-HCM study investigators. Mavacamten for treatment of symptomatic obstructive hypertrophic cardiomyopathy (EXPLORER-HCM): a randomised, double-blind, placebo-controlled, phase 3 trial. Lancet. 2020;396(10253):759-769. (Among 251 adults with symptomatic obstructive hypertrophic cardiomyopathy treated with mavacamten [starting dose 5 mg] or placebo for 30 weeks, the compositive clinical beneficial response occurred in 37% vs 17% with decreases in left ventricular outflow gradients and increases in peak oxygen consumption increased with mavacamten, while adverse event rates were similar [overall 88% vs 79%; serious 8% vs 9%] and there were no liver related serious adverse events; no mention of ALT elevations). 32871100
Mavacamten (Camzyos) for obstructive hypertrophic cardiomyopathy. Med Lett Drugs Ther. 2022;64(1652):89-91. (Concise review of the mechanism of action, clinical efficacy, safety, and costs of mavacamten shortly after its approval for treatment of obstructive hypertrophic cardiomyopathy mentions side effects of dizziness and syncope and that mavacamten can decrease the left ventricular ejection fraction and must be carefully monitored and titrated to avoid excessive dosing). 35657364
Yukselen Z, Raju AKV, Kumar PA, Ujjawal A, Dasari M, Parajuli S, Nakhla M, et al. A real‑world pharmacovigilance study of FDA Adverse Event Reporting System (FAERS) for mavacamten. Am J Cardiovasc Drugs. 2024;24:791-799. (Analysis of spontaneous reports made to the FDA’s Adverse Event Reporting System (FAERS) between 2022 and 2023 identified 1004 events attributed to mavacamten, commonly mentioned being dyspnea, dizziness, fatigue, chest pain, heart failure, atrial fibrillation, and palpations; no reports of ALT or liver enzyme elevations or hepatotoxicity). 39164512
Desai MY, Owens AT, Abraham T, Olivotto I, Garcia-Pavia P, Lopes RD, Elliott P, et al.; ODYSSEY-HCM Investigators. Mavacamten in symptomatic nonobstructive hypertrophic cardiomyopathy. N Engl J Med. 2025;393:961-972. (Among 289 adults with symptomatic but non-obstructive hypertrophic cardiomyopathy treated with mavacamten [starting at 5 mg] vs placebo daily for 48 weeks, mavacamten treated patients had increase in peak oxygen uptake and improvement in symptoms but also to a higher rate of serious adverse events [19% vs 15%] and drug interruptions [15% vs 5%], and left ventricle ejection fractions falling below 50% [22% vs 2%]; no mention of liver-related adverse events). 40888717
Mahana I, Mejia AT, Elman MR, Kamna D, Nguyen O, Volk H, Chen H, et al. Characteristics and outcomes of mavacamten use in 2440 patients with obstructive hypertrophic cardiomyopathy. J Am Heart Assoc. 2025;14:e042488. (Among 2440 patients prescribed mavacamten in 2022 to 2024 and were included in a health claims database, reasons for acute care encounters included heart failure, atrial fibrillation and flutter, stroke, syncope, and myocardial infarction; no mention of liver disease or jaundice). 41147368
Reza N, Dubey A, Mahmud N, Austin MA, Duqueney E, Patel P, Boakye E, et al. Long-term real-world outcomes of mavacamten in symptomatic obstructive hypertrophic cardiomyopathy up to 108 weeks. J Clin Med. 2025;14:8181. (Among 163 adults with symptomatic obstructive hypertrophic cardiomyopathy started on mavacamten between 2022 and 2025 and followed for a median of 60 weeks at a single U.S. referral center, left ventricular outflow tract obstruction and symptoms improved in almost all patients, 90% being asymptomatic at 2 years and only 6 patients permanently discontinued therapy, five for cardiac reasons, none for non-cardiac drug-related adverse events; no mention of ALT elevations or hepatotoxicity). 41303215

## OTHER REFERENCE LINKS

1. Recent References on Mavacamten: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Mavacamten)%20AND%20Human%5bMesh%5d%20AND%20(jaundice%20OR%20bile%20duct%20diseases%20OR%20liver%20OR%20liver%20diseases%20OR%20hepatitis,%20toxic%5bMesh%5d)%20AND%20(%222009/1/1%22%5bEDat%5d:%222999/12/31%22%5bEDat%5d))

2. Trials on Mavacamten: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Mavacamten)